# Echinacea

## OVERVIEW

### Introduction

Echinacea is a popular herbal medication and extract derived from a flowering plant (Echinacea purpurea) that is native to the United States, East of the Rocky Mountains. Echinacea has been used mostly for treating and preventing the common cold and other upper respiratory illnesses. While echinacea is generally well tolerated with only few and minor adverse effects, there have been isolated reports of serum enzyme elevations and clinically apparent liver injury attributed to its use.

### Background

Echinacea (ek" i nay' sha) is a widely used herb derived from the perennial plant, Echinacea purpurea, also known as American coneflower which is native to North America. The above ground parts and roots of the echinacea plant are used either fresh or dried to make teas, juice, extracts, capsules or tablets. The major use is treatment or prevention of upper respiratory infections, but it is also purported to improve immune function and protect against other viral, bacterial and fungal infections, as well as to alleviate anxiety, migraine headaches, dyspepsia, skin rashes and bee stings. There are at least 9 species of echinacea which may vary in therapeutic activities. Extracts of Echinacea purpurea, pallida and angustifolia are the most frequently used and are found in hundreds of commercial herbal and dietary products. The active ingredients of echinacea are not well defined, but plant extracts contain multiple polysaccharides, volatile oils, caffeic and ferulic acid derivatives, flavonoids, alkamides and polyenes. Controlled trials of echinacea in prevention and treatment of common upper respiratory illnesses have yielded mixed results and most systematic reviews have concluded that there is little evidence for its therapeutic effectiveness. On the other hand, echinacea extracts have been repeatedly found to be well tolerated and without major adverse events. The most common adverse events reported have been minor gastrointestinal upset and skin rashes. Rare instances of allergic reactions including urticaria, angioedema and anaphylaxis have been described.

### Hepatotoxicity

In multiple controlled trials, echinacea by itself has not been linked to liver injury, either in the form of transient serum enzyme elevations or clinically apparent acute liver injury. Nevertheless, there have been isolated case reports of clinically apparent liver injury with jaundice, and summary reports from national registries of adverse reactions have reported elevated serum aminotransferase levels and toxic hepatitis attributed to echinacea. Few details of the liver injury were available but in two published reports, hepatitis with jaundice arose 1 to 3 weeks after starting echinacea extracts with mild jaundice, prominent ALT and AST elevations and rapid and complete recovery on stopping. Autoimmune features were present in one case, but neither case had features of hypersensitivity (fever, rash, lymphadenopathy or eosinophilia). Because of the variability in the constituents of echinacea products, it is unclear whether the cases were due to a particular species or method of preparation or contamination of the product.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which some preparations of echinacea might cause liver injury is not known but may be due to a contaminant or mislabeling of the product. However, because echinacea has been linked to rare instances of severe allergic reactions, the isolated cases of hepatitis may represent hepatic manifestations of hypersensitivity. Echinacea-drug interactions have not been well defined. While some echinacea preparations demonstrate interference with CYP1A2 and 3A4 activity in vitro and in vivo, the clinical significance of these interactions has not been shown.

### Outcome and Management

Patients on echinacea who develop unexplained symptoms such as fatigue, nausea, abdominal pain or dark urine should have routine liver tests drawn and discontinue the herb if there are any abnormalities.

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Echinacea – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/echinacea)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Echinacea angustifolia, extract | 84696-11-7 | Herbal Extract | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2019

Abbreviations used: HDS, herbal and dietary supplements

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; echinacea is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; echinacea is not discussed).
Echinacea. In, PDR for herbal medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 266-75. (Compilation of short monographs on herbal medications and dietary supplements).
Melchart D, Walther E, Linde K, Brandmaier R, Lersch C. Echinacea root extracts for the prevention of upper respiratory tract infections: a double blind, placebo-controlled randomized trial. Arch Fam Med 1998; 7: 541-5. (Among 302 healthy adults treated with E. purpurae or E. angustifolia extracts or placebo twice daily for 12 weeks, the incidence and time to a respiratory tract infection was similar in the 3 groups and there were no serious adverse events). 9821828
Mullins RJ. Echinacea-associated anaphylaxis. Med J Aust 1998; 168: 170-1. (37 year old woman with a history of asthma and multiple allergies developed throat burning, chest tightness and urticaria within minutes of swallowing an echinacea preparation which resolved within a few hours, later showing positive skin reactions and RAST testing results with echinacea extract). 9507713
Brinkeborn RM, Shah DV, Degenring FH. Echinaforce and other Echinacea fresh plant preparations in the treatment of the common cold. A randomized, placebo controlled, double-blind clinical trial. Phytomedicine 1999; 6: 1-6. (Among 246 adults with a common cold treated with one of 3 echinacea preparations or placebo, symptom scores were less with two of the herbal preparations and the most frequent adverse event was transient and mild nausea). 10228604
Henneicke-von Zepelin H, Hentschel C, Schnitker J, Kohnen R, Köhler G, Wüstenberg P. Efficacy and safety of a fixed combination phytomedicine in the treatment of the common cold (acute viral respiratory tract infection): results of a randomised, double blind, placebo controlled, multicentre study. Curr Med Res Opin 1999; 15: 214-27. (Among 263 patients with a common cold treated with an herbal mixture containing echinacea or placebo for 7-9 days, total symptom scores improved faster with the herbal product, rates of adverse reactions were similar in the two groups and no serious adverse events were reported). 10621929
Mullins RJ, Heddle R. Adverse reactions associated with echinacea: the Australian experience. Ann Allergy Asthma Immunol 2002; 88: 42-51. (Report of 5 patients with allergic reactions to echinacea [2 anaphylaxis, 2 asthma, 1 rash], several with recurrence on rechallenge and review of Australian adverse drug reports identified 26 cases of suspected IgE mediated hypersensitivity reactions to echinacea; similar cases attributed to echinacea were also found in US, UK, Canadian and New Zealand registries). 11814277
Barrett BP, Brown RL, Locken K, Maberry R, Bobula JA, D'Alessio D. Treatment of the common cold with unrefined echinacea. A randomized, double-blind, placebo-controlled trial. Ann Intern Med 2002; 137: 939-46. (Among 148 college students with early symptoms of a common cold treated with echinacea or placebo for up to 10 days, the severity and duration of symptoms were similar in the two groups and adverse events were mild and uncommon). 12484708
Ernst E. The risk-benefit profile of commonly used herbal therapies: Ginkgo, St. John's Wort, Ginseng, Echinacea, Saw Palmetto, and Kava. Ann Intern Med 2002; 136: 42-53. (Review of the efficacy and safety of common herbal therapies including echinacea mentions that data on its efficacy in preventing upper respiratory infections were inconclusive, and that adverse effects were rare but included allergic reactions which can be severe and include hepatitis). 11777363
Schiano TD. Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis 2003; 7: 453-73. (Comprehensive review of herbal associated hepatotoxicity; echinacea is not listed as causing hepatotoxicity). 12879994
Taylor JA, Weber W, Standish L, Quinn H, Goesling J, McGann M, Calabrese C. Efficacy and safety of echinacea in treating upper respiratory tract infections in children: a randomized controlled trial. JAMA 2003; 290: 2824-30. (Among 407 children who developed an upper respiratory infection and were treated with echinacea or placebo for up to 10 days, the duration and severity of symptoms were not different in the two groups while rash was more frequent with echinacea [7.1% vs 2.7%]). 14657066
Yale SH, Liu K. Echinacea purpurea therapy for the treatment of the common cold: a randomized, double-blind, placebo-controlled clinical trial. Arch Intern Med 2004; 164: 1237-41. (Among 128 adults with an acute upper respiratory infection treated with echinacea [aerial portions of E. purpurea] or placebo for up to 14 days, symptom scores improved in both groups at a similar rate, and few adverse events were reported, mostly headache, dry mouth, nausea and abdominal pain, none considered severe). 15197051
Cohen HA, Varsano I, Kahan E, Sarrell EM, Uziel Y. Effectiveness of an herbal preparation containing echinacea, propolis, and vitamin C in preventing respiratory tract infections in children: a randomized, double-blind, placebo-controlled, multicenter study. Arch Pediatr Adolesc Med 2004; 158: 217-21. (Among 430 children [ages 1 to 5 years] treated with a commercial mixed echinacea product or placebo for 12 weeks, the number of upper respiratory infections and days of fever were less in the echinacea treated children, and adverse events were uncommon and mild and similar in rates between the two groups). 14993078
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none attributed to echinacea). 15390328
Naser B, Lund B, Henneicke-von Zepelin HH, Köhler G, Lehmacher W, Scaglione F. A randomized, double-blind, placebo-controlled, clinical dose-response trial of an extract of Baptisia, Echinacea and Thuja for the treatment of patients with common cold. Phytomedicine 2005; 12: 715-22. (Among 91 adults with an upper respiratory infection treated with 1 of 2 doses of an herbal mixture containing echinacea or placebo for 3-12 days, facial tissue use was less on day 2 with the herbal product than placebo). 16323289
Turner RB, Bauer R, Woelkart K, Hulsey TC, Gangemi JD. An evaluation of Echinacea angustifolia in experimental rhinovirus infections. N Engl J Med 2005; 353: 341-8. (Amng 399 healthy adults treated with 1 of 3 preparations of E. angustifolia root extract or placebo and challenged with rhinovirus type 39, there were no differences in duration or severity of upper respiratory tract symptoms and adverse event rates were similar, the most common complaints being gastrointestinal). 16049208
Barnes J, Anderson LA, Gibbons S, Phillipson JD. Echinacea species (Echinacea angustifolia (DC.) Hell., Echinacea pallida (Nutt.) Nutt., Echinacea purpurea (L.) Moench): a review of their chemistry, pharmacology and clinical properties. J Pharm Pharmacol 2005; 57: 929-54. (Review of the chemistry, pharmacology and clinical efficacy of echinacea stresses the differences between different species in chemical constituents as well as in vitro and clinical effects and adverse events, which are generally mild but may include allergic reactions and herb-drug interactions). 16102249
Huntley AL, Thompson Coon J, Ernst E. The safety of herbal medicinal products derived from Echinacea species: a systematic review. Drug Saf 2005; 28: 387-400. (Systematic review of the literature on adverse events attributed to echinacea mentions that most studies did not report or reported no or only mild adverse events, largely gastrointestinal and frequently at a similar frequency as with placebo; mentions 8 case reports and data from 5 national registries that note serious allergic reactions including anaphylaxis, erythema nodosum and DRESS syndrome, but no mention of hepatotoxicity). 15853441
Kocaman O, Hulagu S, Senturk O. Echinacea-induced severe acute hepatitis with features of cholestatic autoimmune hepatitis. Eur J Intern Med 2008; 19: 148. (45 year old man developed jaundice within a month of starting an echinacea root extract [1500 mg daily] [bilirubin 2.8 mg/dL, ALT 1260 U/L, Alk P 984 U/L, INR 1.3, SMA 1:80], resolving within one month of stopping). 18249315
Freeman C, Spelman K. A critical evaluation of drug interactions with Echinacea spp. Mol Nutr Food Res 2008; 52: 789-98. (A systematic review of the literature found little evidence of clinically significant echinacea-drug interactions, but the number and quality of rigorous scientific studies were limited). 18618481
Wallace RB, Gryzlak BM, Zimmerman MB, Nisly NL. Application of FDA adverse event report data to the surveillance of dietary botanical supplements. Ann Pharmacother 2008; 42: 653-60. (Description of the FDA’s Center for Food Safety and Applied Nutrition Adverse Event Reporting System [CAERS] reporting system and data from 1999 to 2003 for 6 commonly used herbal products including echinacea [68 of 362 reports], often in a multiingredient product [40:59%], most commonly gastrointestinal [23] and dermatologic symptoms [7], but one was “elevated liver function test results”). 18397972
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. (Among 521 cases of drug induced liver injury submitted to a Spanish registry, 13 [2%] were due to herbals, but none were attributed to echinacea). 19159172
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbal medicines to a Swedish Registry between 1987 and 2006 found 63 reports of adverse reactions to echinacea [8%], including 5 to “increased hepatic enzymes”, 2 to “elevated transaminase” and 2 for “liver necrosis”, one of which was fatal in a 28 year old male who had taken “purple coneflower” for 6 months). 19650152
Maskatia ZK, Baker K. Hypereosinophilia associated with echinacea use. South Med J 2010; 103: 1173-4. (58 year old man with allergic rhinitis and multiple medical problems was found to have marked hypereosinophilia [17,800 per µL] that was unresponsive to medical therapies, but resolved spontaneously when echinacea supplements were stopped). 20890257
Barrett B, Brown R, Rakel D, Mundt M, Bone K, Barlow S, Ewers T. Echinacea for treating the common cold: a randomized trial. Ann Intern Med 2010; 153: 769-77. (Among 719 patients with early symptoms of a common cold treated with open-label echinacea, or blinded echinacea or placebo, or no pills for 5 days, there were no statistically significant differences in illness severity or duration in the four groups and adverse event rates were similar except that headache was more frequent in the no-pill group). 21173411
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs and supplements; does not mention or discuss echinacea). 22928722
Jawad M, Schoop R, Suter A, Klein P, Eccles R. Safety and efficacy profile of Echinacea purpurea to prevent common cold episodes: a randomized, double-blind, placebo-controlled trial. Evid Based Complement Alternat Med 2012; 2012: 841315. (Among 755 healthy adults treated with an echinacea extract or placebo for 4 months, cold episodes were less with echinacea [42% vs 52%], while product related adverse event rates were similar [9.9% vs 9.7%] and there were no serious adverse events with echinacea). 23024696
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of literature on HDS associated liver injury does not discuss echinacea). 23121117
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60:1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to a known echinacea containing product). 25043597
Karsch-Völk M, Barrett B, Kiefer D, Bauer R, Ardjomand-Woelkart K, Linde K. Echinacea for preventing and treating the common cold. Cochrane Database Syst Rev 2014; (2): CD000530. (Systematic review of 24 controlled trials [with 4631 participants] of echinacea for preventing or treating the common cold concluded that the benefits of echinacea have not been proven, although many prophylaxis trials showed a trend towards a positive effect). 24554461
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology 2015; 148: 517-32. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver does not mention or discuss echinacea). 25500423
Gabranis I, Koufakis T, Papakrivos I, Batala S. Echinacea-associated acute cholestatic hepatitis. J Postgrad Med 2015; 61: 211-2. (44 year old man developed fatigue shortly after a 5 day course of an echinacea root extract [bilirubin 4.6 mg/dL, ALT 594 U/L, Alk P 269 U/L, GGT 442 U/L, INR 1.49], resolving within 3 months). 26119446
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: a tabular listing and clinical characteristics. Int J Mol Sci 2016; 17. pii: E537. (Listing of published cases of liver injury from HDS products does not mention or discuss echinacea in the listings). 27070596
Ardjomand-Woelkart K, Bauer R. Review and assessment of medicinal safety data of orally used echinacea preparations. Planta Med 2016; 82: 17-31. (Systematic review of the literature on the safety of oral echinacea concluded that adverse events during treatment are generally mild and not clearly attributable to the herb and that long term studies reported no toxicological concerns; discusses a case report of cholestatic hepatitis [Kocaman 2008]). 26441065
Asher GN, Corbett AH, Hawke RL. Common herbal dietary supplement-drug interactions. Am Fam Physician 2017; 96: 101-7. (Review of herbal-drug interactions of the commonly used herbal supplements including echinacea for which there are conflicting results of effects on CYP 1A2 and 3A4, for which reason “caution should be taken”). 28762712
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not mention or discuss echinacea). 27402097
Wong LL, Lacar L, Roytman M, Orloff SL. Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc 2017; 49: 322-5. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic necrosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products, but echinacea was not implicated in any case). 28219592

## OTHER REFERENCE LINKS

1. Recent References on Echinacea: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Echinacea/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Echinacea: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Echinacea)